# Esketamine

## OVERVIEW

### Introduction

Esketamine is unique antidepressant administered as an intranasal spray as therapy of treatment- resistant depression in adults. Esketamine has not been associated with serum enzyme elevations during treatment nor to instances of clinically apparent acute liver injury.

### Background

Esketamine (es ket’ a meen) is an N-methyl-D-aspartate (NMDA) receptor antagonist that is used as an intranasal spray for treatment of adults with treatment-resistant depression. Esketamine is as isomer of ketamine, an anesthetic that was largely abandoned because of adverse events including dissociation syndrome. Ketamine later became a drug of abuse because of its psychotropic activities including dissociation and euphoria. Ketamine was used off label and experimentally to treat major depression and appeared to have rapid dramatic effects in anecdotal reports and in small controlled trials. Esketamine, the S-enantiomer of ketamine, was claimed to have more of an antidepressant and less sedative effect and was developed specifically as a therapy for treatment-resistant major depression. Multiple randomized controlled trials demonstrated that the addition of nasal spray esketamine to oral antidepressants significantly improved depression, as measured by standard scoring systems, in comparison to placebo in patients who had failed to respond to standard antidepressants. Esketamine was approved for this use in the United States in 2019. It is available under the commercial name Spravato as a nasal spray administered under medical supervision twice weekly for the first 4 weeks and then once weekly for 4 weeks of treatment, followed by once weekly or every other week thereafter. Esketamine is considered a Schedule III drug because of its potential for addiction and abuse. It has many adverse effects for which reason it is available only as a part of an FDA Risk Evaluation and Mitigation Strategy (REMS) program requiring training in its administration and direct monitoring of its effects. Common side effects include sedation and feelings of dissociation, dizziness, vertigo, nausea, anxiety, lethargy, hypoesthesia, nausea and vomiting, cystitis and lower urinary tract symptoms, and increases in blood pressure (within 1 to 2 hours of administration). Less common but potentially severe adverse events include suicidal ideation and behaviors, severe dissociation syndromes, interstitial cystitis, and embryo-fetal toxicity.

### Hepatotoxicity

In patients on oral antidepressants, liver test abnormalities were no more frequent with the addition of nasal spray esketamine than with placebo. In the pivotal trials of esketamine as therapy of treatment- resistant depression, mean serum ALT, AST and alkaline phosphatase levels decreased during active therapy and there were no reports of serum enzyme elevations, jaundice, hepatitis, discontinuations for serum enzyme elevations or serious hepatic adverse events. Although long term ketamine use is known to be associated with bile duct injury and episodes of cholestatic jaundice, esketamine has not been linked to a similar pattern of biliary injury or cholestatic hepatitis when used under medical supervision to treat depression. There has been little clinical experience with long term use of esketamine, but no instances of clinically apparent liver injury have as yet been reported with its use.

Likelihood score: E* (unproven but suspected potential cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which esketamine might cause liver injury is not known. Esketamine is metabolized by the liver via the microsomal cytochrome P450 system (predominantly CYP 3A4 and 2B6), but plasma levels are minimally affected by agents that induce or inhibit the microsomal enzyme system. The liver injury reported with ketamine use appeared to be due to bile duct epithelial injury leading to bile duct strictures and cholestatic liver injury, in a manner similar to the urothelial cell injury and ureteral strictures that has been well documented to occur with ketamine use and abuse.

Drug Class: Antidepressant Agents

Other Drugs in the Subclass: [underlined: Ketamine]

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Esketamine – Spravato®

DRUG CLASS

Antidepressant Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/drugInfo.cfm?setid=d81a6a79-a74a-44b7-822c-0dfa3036eaed)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Esketamine | 33643-46-8 (https://pubchem.ncbi.nlm.nih.gov/substance/135159313) | C13-H16-Cl-N-O

## ANNOTATED BIBLIOGRAPHY

References updated: 18 October 2019

Zimmerman HJ. Antidepressants. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 493-8. (Expert review of hepatotoxicity of antidepressants published in 1999; esketamine and ketamine are not discussed).
Larrey D, Ripault MP. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 443-62. (Review of antidepressant hepatotoxicity; ketamine and esketamine are not discussed).
O'Donnell JM, Shelton RC. Pharmacotherapy of depression and anxiety disorders. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 267-78. (Textbook of pharmacology and therapeutics).
https://www.accessdata.fda.gov/drugsatfda_docs/nda/2019/211243Orig1s000MedR.pdf (FDA website with medical review of efficacy and safety of esketamine in support of its approval; laboratory test results discussed on pages 215-6).
Voican CS, Corruble E, Naveau S, Perlemuter G. (2014). Antidepressant-induced liver injury: a review for clinicians. Am J Psychiatry. (Review of the frequency and clinical features of drug induced liver injury due to antidepressants; SSRIs such as venlafaxine, fluoxetine, sertraline and paroxetine are discussed, but not esketamine).
Singh JB, Fedgchin M, Daly E, Xi L, Melman C, De Bruecker G, Tadic A, et al. (2016). Intravenous esketamine in adult treatment-resistant depression: a double-blind, double-randomization, placebo-controlled study. Biol Psychiatry. (Among 30 patients with treatment resistant depression treated with single intravenous doses of esketamine [0.2 or 0.4 mg/kg] or placebo, depression scales improved more with esketamine [-16.8 and -16.9] than placebo [-3.8] and side effects were somewhat dose related, particularly dissociation, but “no clinically significant changes in laboratory tests … were observed”).
Canuso CM, Singh JB, Fedgchin M, Alphs L, Lane R, Lim P, Pinter C, et al. (2018). Efficacy and safety of intranasal esketamine for the rapid reduction of symptoms of depression and suicidality in patients at imminent risk for suicide: results of a double-blind, randomized, placebo-controlled study. Am J Psychiatry. (Among 68 patients with major depression on oral antidepressants treated with addition of esketamine [84 mg] or placebo intranasally twice weekly for 4 weeks, depression scores were significantly improved compared to placebo at 4 and 24 hours but not at 25 days, and side effects were greater with esketamine including nausea [37% vs 3%], dizziness [31% vs 13%], headache [31% vs 26%] and dissociation [31% vs 13%]; no mention of ALT elevations or laboratory abnormalities).
Morrison RL, Fedgchin M, Singh J, Van Gerven J, Zuiker R, Lim KS, van der Ark P, et al. (2018). Effect of intranasal esketamine on cognitive functioning in healthy participants: a randomized, double-blind, placebo-controlled study. Psychopharmacology (Berl). (Among 24 healthy adult volunteers treated with a single dose of intranasal esketamine [84 mg] or placebo in a crossover design, cognitive performance was impaired at 40 minutes but not 2, 4 or 6 hours after esketamine dosing and “overall, no clinically significant effect on the laboratory parameters … was observed”).
Daly EJ, Singh JB, Fedgchin M, Cooper K, Lim P, Shelton RC, Thase ME, et al. (2018). Efficacy and safety of intranasal esketamine adjunctive to oral antidepressant therapy in treatment-resistant depression: a randomized clinical trial. JAMA Psychiatry. (Among 67 patients with treatment resistant depression treated with esketamine [28, 56 or 84 mg] intranasally twice weekly for 2 weeks followed by open label therapy, changes in depression rating scores were greater with esketamine in a dose related manner while common side effects were dizziness, nausea, headache, hypertension and dissociation, 3 subjects [5%] stopping therapy early; no mention of laboratory test abnormalities).
Molero P, Ramos-Quiroga JA, Martin-Santos R, Calvo-Sánchez E, Gutiérrez-Rojas L, Meana JJ. (2018). Antidepressant efficacy and tolerability of ketamine and esketamine: a critical review. CNS Drugs. (Review of the mechanism of action and history of clinical evaluation of ketamine and esketamine as therapy of depression, and discussion of controversy of their safety and long term efficacy in comparison to conventional treatments of depression).
Short B, Fong J, Galvez V, Shelker W, Loo CK. (2018). Side-effects associated with ketamine use in depression: a systematic review. Lancet Psychiatry. (Review of the reported side effects of ketamine use in depression based upon 60 studies in 899 patients, usually short term [80%] using iv therapy [82%], the most common effects being psychiatric including anxiety, sedation and dissociation; liver injury has been reported anecdotally and with prolonged infusions or ketamine abuse).
Popova V, Daly EJ, Trivedi M, Cooper K, Lane R, Lim P, Mazzucco C, et al. (2019). Efficacy and safety of flexibly dosed esketamine nasal spray combined with a newly initiated oral antidepressant in treatment-resistant depression: a randomized double-blind active-controlled study. Am J Psychiatry. (Among 67 adults with treatment resistant depression started on a new antidepressant combined with esketamine [54 or 86 mg] or placebo nasal spray twice weekly for 4 weeks, depression scores improved more with esketamine [-21 vs -17], and side effects were greater including dissociation [26% vs 4%], nausea [26% vs 6%] and vertigo [26% vs 3%], leading 7% of patients to stop therapy; no mention of ALT or laboratory test abnormalities).
Kim J, Farchione T, Potter A, Chen Q, Temple R. (2019). Esketamine for treatment-resistant depression - first FDA-approved antidepressant in a new class. N Engl J Med. (Review of the FDA assessment of efficacy and safety of esketamine that led to the approval as therapy of treatment resistant depression and requirement for a REMS program for monitoring based upon its common side effects and potential for abuse, but also because of lack of data on its long term efficacy and safety).
(2019). Esketamine nasal spray (Spravato) for treatment-resistant depression. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and costs of esketamine nasal spray shortly after its approval as therapy of treatment resistant depression, does not mention hepatotoxicity or serum enzyme elevations as a potential side effect of its use).
Daly EJ, Trivedi MH, Janik A, Li H, Zhang Y, Li X, Lane R, et al. Efficacy of esketamine nasal spray plus oral antidepressant treatment for relapse prevention in patients with treatment-resistant depression: a randomized clinical trial. JAMA Psychiatr 2019 Jun 5. [Epub ahead of print] (Among 297 patients who achieved remission or a stable response on a 16 week course of an oral antidepressant and nasal spray esketamine and were then either continued on esketamine or switched to placebo, relapses occurred more frequently with placebo [45% and 58%] than with continuing esketamine [27% and 26%], but side effects were less; no mention of ALT or other laboratory test abnormalities).
Fedgchin M, Trivedi M, Daly EJ, Melkote R, Lane R, Lim P, Vitagliano D, et al. (2019). Efficacy and safety of fixed-dose esketamine nasal spray combined with a new oral antidepressant in treatment-resistant depression: results of a randomized, double-blind, active-controlled study (TRANSFORM-1). Int J Neuropsychopharmacol. (Among 346 patients with treatment resistant depression treated with an oral antidepressant and nasal spray esketamine [56 or 84 mg] or placebo twice weekly for 4 weeks, depression scores decreased more on esketamine than placebo, but the differences were not statistically significant at week 4, and side effects were greater with esketamine; no mention of ALT or laboratory abnormalities).
Ritter P, Findeis H, Bauer M. (2019). Ketamine in the treatment of depressive episodes. Pharmacopsychiatry. (Review of the chemistry, mechanism of action and clinical efficacy of ketamine as a therapy of major depression, in which it demonstrates dramatic rapid clinical effects, but usually in studies that could not be “blinded” because of its side effects; most studies using intravenous therapy, careful monitoring and thrice weekly infusions for optimal effects).

## OTHER REFERENCE LINKS

1 Recent References on Esketamine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/pubmed?cmd=search&pubmedfilters=true&term=(Esketamine/AE)%20AND%20Human%5bMH%5d%20AND%20(drug%20induced%20liver%20injury%20OR%20jaundice/CI%20OR%20bile%20duct%20diseases/CI%20OR%20liver/DE%20OR%20liver%20diseases/CI)%20AND%20(%221900/1/1%22%5bEDat%5d:%222999/12/31%22%5bEDat%5d))
2 Trials on Esketamine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Esketamine)